# Barbiturates

## OVERVIEW

### Introduction

Barbiturates are structurally related compounds with sedative and hypnotic activities, some of which (phenobarbital and mephobarital) are also used as anticonvulsants. Phenobarbital has been clearly linked to cases of idiosyncratic acute liver injury, resembling the immunoallergic hepatotoxicity of other aromatic anticonvulsants such as phenytoin and carbamazepine. In contrast, the other conventional sedative barbiturates have not been linked to serum enzyme elevations during therapy and clinically apparent acute liver injury due to the sedative barbiturates is extremely rare, if it occurs at all.

### Background

Barbiturates are a family of compounds that have sedative and hypnotic activities and act as nonselective central nervous system (CNS) depressants. The barbiturates were introduced into medical practice in the early 20^th^ century, used as a sleeping aid and in treatment of schizophrenia. However, with chronic use they often cause psychological and physical dependence and have serious adverse effects, including agitation, respiratory depression and daytime somnolence. Phenobarbital (fee" noe bar' bi tal) given in lower doses was found to have anticonvulsant activity and has been used extensively as an anticonvulsant, particularly in children. Phenobarbital appears to act by suppression of spread of seizure activity by enhancing the effect of gamma aminobutyric acid (GABA). Phenobarbital has been linked to instances of acute liver injury and is discussed separately as an anticonvulsant. The barbiturates that are used as sedatives and hypnotics, in contrast, have not been linked to cases of acute or chronic liver injury and are discussed together below.

Amobarbital, pentobarbital and secobarbital are used as sedatives and hypnotics and not as anticonvulsants. These and many other synthetic barbiturates were introduced into medical use in the United States in the early part of the 20^th^ century as sedatives, hypnotics (short term treatment of insomnia) and preanesthetic agents. They are now rarely used, having been replaced by more effective and better tolerated sedatives and hypnotics such as the benzodiazepines and benzodiazepine receptor agonists. Amobarbital (am" oh bar' bi tal) and pentobarbital (pen” toe bar’ bi tal) are currently available, but only as solutions for parenteral administration, being used largely as preanesthetic agents. Secobarbital is available as a 100 mg capsule generically and under the brand name Seconal. Current indications for the barbiturates include short term treatment of insomnia and as a preanesthetic agent or sedative for a minor procedure or imaging study. The recommended dose of secobarbital in adults is 100 mg at bedtime or 200 to 300 mg 1 to 2 hours before surgery. Barbiturates that are no longer available in the United States include butalbital, butabarbital, mephobarbital, methohexital, and thiopental. Secobarbital, amobarbital and pentobarbital are classified as a Schedule II substances, indicating that they have definite potential for physical and psychological dependence and abuse. Frequent side effects include drowsiness, sedation, impairment of mental and physical abilities, hypotension, bradycardia, syncope, nausea, vomiting, headache, and skin rash. When given chronically, the barbiturates can cause psychological and physical dependence and their withdrawal can be associated with agitation, irritability, confusion, insomnia, and vivid dreams.

### Hepatotoxicity

Despite wide scale previous use, there is little evidence that the conventional barbiturates used as sedatives or preanesthetic agents can cause liver injury, either serum enzyme elevations during therapy or clinically apparent acute liver disease. There have been no reports of liver injury associated with secobarbital, butabarbital or amobarbital. The barbiturates can cause allergic reactions and skin rashes, which may be accompanied by mild liver injury. Paradoxically, phenobarbital has been linked to many instances of hypersensitivity reactions with accompanying liver disease that can be severe, including drug reaction with eosinophilia and systemic symptoms (DRESS) syndrome, Stevens Johnson syndrome [SJS] and toxic epidermal necrolysis [TEN], while the other barbiturates have not. The barbiturates are also potent inducers of many hepatic enzymes. In animal models, phenobarbital causes enlargement of hepatocytes with marked increases in protein and lipid content of the endoplasmic reticulum, causing an increased granularity to the hepatocyte cytoplasm. Hepatic enzymes that are induced with chronic barbiturate use include multiple microsomal enzymes such as CYP 1A2, 2C9, 2C19 and 3A4 as well as glucuronyl transferase, delta-aminolevulinic acid, and aldehyde dehydrogenase. Thus, chronic use of barbiturates may increase the metabolism of many drugs and endogenous substances including steroid hormones, cholesterol, bile salts and vitamins.

Likelihood score for amobarbital, pentobarbital and secobarbital: E (unlikely causes of clinically apparent liver injury).

### Mechanism of Injury

The reason why phenobarbital, but not amobarbital, butabarbital or secobarbital has been linked to hepatotoxicity is not known, but may merely be that the conventional barbiturates are infrequently used and used in relatively low doses for short periods only. The mechanism of phenobarbital hepatotoxicity is thought to be hypersensitivity and it commonly presents with DRESS syndrome. Hypersensitivity reactions can occur with other barbiturates, but hepatic involvement has not been described in the literature.

Drug Class: Sedatives and Hypnotics

Drugs in the Subclass, Barbiturates: Amobarbital, Butabarbital, Phenobarbital, Secobarbital

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amobarbital – Generic, Amytal®

Phenobarbital – Generic

Secobarbital – Generic, Seconal®

DRUG CLASS

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Barbiturates)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Amobarbital | 57-43-2 | C11-H18-N2-O3
Phenobarbital | 50-06-6 | C12-H12-N2-O3
Secobarbital | 76-73-3 | C12-H18-N2-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 03 October 2021

Zimmerman HJ. Anticonvulsants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp.498-516. (Expert review of anticonvulsants and liver injury published in 1999; mentions that liver injury from phenobarbital is rare, but it has been implicated in at least 15 cases of clinically apparent injury, both hepatocellular and cholestatic; potential hepatotoxicity of other barbiturates is not discussed).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-442. (Review of anticonvulsant induced liver injury mentions that phenobarbital is the oldest aromatic anticonvulsant and can cause elevations in serum GGT and Alk P but is a rare cause of liver injury, reported cases usually associated with hypersensitivity reactions).
Smith MD, Metcalf CS, Wilcox KS. Pharmacology of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
Mihic J, Mayfield J, Harris RA. Barbiturates. Hypnotics and sedatives. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 339-54. (Textbook of pharmacology and therapeutics mentions that the barbiturates were once used extensively, but have been replaced by the much safer benzodiazepines).
Welton DG. (1950). Exfoliative dermatitis and hepatitis due to phenobarbital. J Am Med Assoc. (25 year old pregnant woman developed rash, followed by facial and peripheral edema, itching, erythema and exfoliation, fever to 104oC after 6 weeks of phenobarbital [white blood count 73,000, 32% eosinophils], jaundiced for a few weeks but ultimately recovered).
McGeachy TE, Bloomer WE. (1953). The phenobarbital sensitivity syndrome. Am J Med. (3 cases of severe phenobarbital reactions seen between 1933 and 1947; two men and one woman, ages 27 to 41 years, developing rash, desquamation, fever, delirium and jaundice within 1-2 weeks of starting drug; one instance was fatal).
Pagliaro L, Campesi G, Aguglia F. (1969). Barbiturate jaundice. Report of a case due to a barbital-containing drug, with positive rechallenge to phenobarbital. Gastroenterology. (31 year old woman developed rash, fever, facial edema after 2 doses of "barbital" by 7 days developed jaundice [bilirubin 24.1 mg/dL, ALT 200 U/L, ALk P 15 BU], with prolonged jaundice; rechallenge with phenobarbital caused recurrence of fever, rash and jaundice [19 mg/dL]; three biopsies were done, but vanishing bile duct syndrome was evidently not present).
Weisburst M, Self T, Peace R, Cooper J. (1976). Jaundice and rash associated with the use of phenobarbital and hydrochlorothiazide. South Med J. (18 year old woman developed rash followed by fever, anorexia, lymphadenopathy and jaundice 6 weeks after starting phenobarbital for hypertension [bilirubin 7.2 mg/dL, AST 250 U/L, Alk P 350 U/L], resolving rapidly although no mention of drug being stopped).
Shapiro PA, Antonioli DA, Peppercorn MA. (1980). Barbiturate-induced submassive hepatic necrosis. Am J Gastroenterol. (71 year old woman developed rash on phenytoin and was switched to mephobarbital and 3 months later developed anorexia, fatigue persisting for 6 weeks to onset of jaundice [bilirubin 5.3 mg/dL, ALT 837 U/L, Alk P 320 U/L], improved slowly but relapsed with restarting phenobarbital; biopsy showed submassive necrosis, ultimately recovering completely; no features of hypersensitivity).
Lane T, Peterson EA. (1984). Hepatitis as a manifestation of phenobarbital hypersensitivity. South Med J. (4 year old boy developed fever and rash about 1 week after starting phenobarbital and 1 week later found to have ALT 273 U/L [no bilirubin reported], rapid improvement with stopping).
Knutsen AP, Anderson J, Satayaviboon S, Slavin RG. (1984). Immunologic aspects of phenobarbital hypersensitivity. J Pediatr. (Seven patients with onset of hypersensitivity 2 to 23 days after starting phenobarbital with fever, pruritic skin rash becoming confluent and desquamating; 2 patients had abnormal liver tests, but without jaundice; 3 had eosinophilia, 3 IgE elevations; 2 decreased C4 levels; several had positive lymphocyte stimulation tests to phenytoin or phenobarbital).
Roberts EA, Spielberg SP, Goldbach M, Phillips MJ. (1990). Phenobarbital hepatotoxicity in an 8-month-old infant. J Hepatol. (8 month old boy with seizures given phenobarbital for 2 weeks developed rash followed by fever with eosinophilia, atypical lymphocytes [bilirubin 2.9 mg/dL, ALT 430 U/L, Alk P 135 U/L], slow recovery, positive lymphocyte cytotoxicity test).
Dayrell-Hart B, Steinberg SA, VanWinkle TJ, Farnbach GC. (1991). Hepatotoxicity of phenobarbital in dogs: 18 cases (1985-1989). J Am Vet Med Assoc. (Description of 18 dogs with phenobarbital induced liver injury, all had sedation and ataxia, 3 were icteric [bilirubin 0.2-4.9 mg/dL, ALT 38-1,830 U/L, Alk P 301-5,240 U/L], liver biopsies showing variable degrees of necrosis, inflammation and fibrosis; 9 dogs died or were euthanized, whereas the others appeared to recover completely).
Di Martino V, Mallat A, Duvoux C, Zafrani ES, Dhumeaux D. (1994). Gastroenterol Clin Biol. (Patient on phenobarbital for 1 month developed fever and rash followed by adenopathy and jaundice [bilirubin 8.7 mg/dL, ALT 22 times ULN, elevated prothrombin time], treated with prednisone and recovered within 1 month).
Wallace SJ. (1996). A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine, but not with phenobarbital; skin rash and Stevens-Johnson syndrome discussed related to phenobarbital).
Foster SF, Church DB, Watson AD. (2000). Effects of phenobarbitone on serum biochemical tests in dogs. Aust Vet J. (Comparison of 10 dogs receiving phenobarbital for seizures with 10 control dogs found slightly higher levels of alkaline phosphatase in treated dogs, with no differences in GGT or bilirubin and mild increases in ALT).
Müller PB, Taboada J, Hosgood G, Partington BP, VanSteenhouse JL, Taylor HW, Wolfsheimer KJ. (2000). Effects of long-term phenobarbital treatment on the liver in dogs. J Vet Intern Med. (12 normal dogs who were given phenobarbital for 29 weeks developed slight rise in Alk P [~50 to 270 U/L] and ALT [27 to 65 U/L], with no change in serum bilirubin, and biopsy showing increase in hepatocyte size and cytoplasmic granularity compatible with enzyme induction, rather than injury or necrosis).
Gaskill CL, Miller LM, Mattoon JS, Hoffmann WE, Burton SA, Gelens HC, Ihle SL, et al. (2005). Liver histopathology and liver and serum alanine aminotransferase and alkaline phosphatase activities in epileptic dogs receiving phenobarbital. Vet Pathol. (Liver biopsies from dogs receiving phenobarbital showed increase in hepatocyte size, granularity and mild injury, but similar although milder changes were found in control dogs; serum enzymes were mildly increased in phenobarbital treated dogs as was CYP 2B activity in liver).
Lachgar T, Touil Y. (2001). Allerg Immunol (Paris). (78 year old woman developed rash and fever 3 weeks after starting phenobarbital [ALT 3 times ULN, eosinophilia], resolving within a month of stopping).
Autret-Leca E, Norbert K, Bensouda-Grimaldi L, Jonville-Béra AP, Saliba E, Bentata J, Barthez-Carpentier MA. (2007). Arch Pediatr. (6 year old girl with epilepsy developed rash and fever 3 weeks after starting phenobarbital, with eosinophilia [ALT 5 times ULN, Alk P 1.5 times ULN], improving clinically with corticosteroid therapy; switched to topiramate and valproate without recurrence).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of all anticonvulsants; phenytoin hepatotoxicity usually occurs as a part of a hypersensitivity syndrome, in 1:10,000 to 1:50,000 persons, 100 published cases, mean onset at 4 weeks, 13% mortality; in contrast, phenobarbital has only rarely been reported to cause liver injury).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 18 cases were attributed to anticonvulsants, no case was attributed to phenobarbital or other barbiturates).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, phenobarbital accounting for 41 cases [0.4%] for an adjusted odds ratio of 6.6; no other barbiturate listed among the 41 most frequently implicated agents).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N, Drug-Induced Liver Injury Network. (2011). Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN Prospective Study. J Pediatr Gastroenterol Nutr. (Among 30 children with drug induced liver injury enrolled in a prospective US database between 2004 and 2008, 8 were due to anticonvulsants [lamotrigine in 3, valproate in 3, phenytoin in 1 and carbamazepine in 1], none were attributed to phenobarbital or other barbiturates).
Sedky K, Nazir R, Joshi A, Kaur G, Lippmann S. (2012). Which psychotropic medications induce hepatotoxicity?. Gen Hosp Psychiatry. (Review of the hepatotoxicity of psychotropic medications; barbiturates are not discussed).
Gaur S, Agnihotri R. (2012). Phenobarbital induced Stevens-Johnson syndrome in a child. Indian J Pharmacol. (12 year old boy developed fever and rash 7 days after switching from phenytoin to phenobarbital [bilirubin 3.1 mg/dL, ALT 187 U/L, Alk P 400 U/L], resolving rapidly upon stopping).
Ruggiero A, Buonuomo PS, Maurizi P, Cefalo MG, Corsello M, Riccardi R. (2007). Stevens-Johnson syndrome in children receiving phenobarbital therapy and cranial radiotherapy. J Neurooncol. (Two children, one boy and one girl, ages 6 and 7 developed rash [SJS/TEN] 26 and 28 days after starting phenobarbital after cranial radiotherapy for brain tumors; liver test results not provided).
Manuyakorn W, Siripool K, Kamchaisatian W, Pakakasama S, Visudtibhan A, Vilaiyuk S, Rujirawat T, et al. (2013). Phenobarbital-induced severe cutaneous adverse drug reactions are associated with CYP2C19*2 in Thai children. Pediatr Allergy Immunol. (Among 40 cases of drug induced severe cutaneous reactions [DRESS or SJS/TEN] seen over 20 years at a single referral hospital in Thailand, 20 were due to phenobarbital, 17 to phenytoin and 3 to carbamazepine; among cases due to phenobarbital, ALT levels average 71 U/L [range 26-4243], weak association found with a CYP2C19*2 variant).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to a barbiturate).
Mason KP, Zurakowski D, Connor L, Karian VE, Fontaine PJ, Sanborn PA, Burrows PE. (2004). Infant sedation for MR imaging and CT: oral versus intravenous pentobarbital. Radiology. (Retrospective review of 2164 infants undergoing 2419 magnetic resonance imaging sessions requiring sedation and given either oral or iv pentobarbital, found that time to onset was faster with iv drug [7 vs 18 min], but quality of sedation and time to recovery were similar as were adverse events [1.3% vs 0.8%; none were liver related], the general findings favoring oral administration).
López-Muñoz F, Ucha-Udabe R, Alamo C. (2005). The history of barbiturates a century after their clinical introduction. Neuropsychiatr Dis Treat. (History of the discovery of the barbiturates and development of synthetic formulations, about 50 of which came to market starting with phenobarbital [Luminol] in 1912, pentobarbital [Neonal] in 1922, most being used as sleeping aids and as therapy of schizophrenia, and later found to have anticonvulsant activity and to be useful in sedation and preanesthesia, but more recently replaced with safer and less addictive therapies).
McCleary K, Barrash J, Granner M, Manzel K, Greider A, Jones R. (2018). The safety and efficacy of propofol as a replacement for amobarbital in intracarotid Wada testing of presurgical patients with epilepsy. Epilepsy Behav. (The difficulty in obtaining amobarbital led to its replacement with propofol in mild sedation, and comparison of efficacy and safety using historical controls suggested similar rates of successful anesthesia and similar rates of adverse events; no mention of liver-related symptoms).
Schlatter J, Kabiche S, Sellier N, Fontan JE. (2018). Oral pentobarbital suspension for children sedation during MR imaging. Ann Pharm Fr. (Among 81 children undergoing magnetic resonance imaging given oral pentobarbital for sedation, the success of obtaining imaging varied by age, being 100% below age 1 but only 42% in 4 to 8 year olds; adverse events were rare but [from a literature review] could include oxygen desaturation, prolonged sedation, paradoxical excitement, and vomiting; no mention of liver injury).

## OTHER REFERENCE LINKS

1 Recent References on Barbiturates: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Barbiturates/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Barbiturates: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Barbiturates)